# Tofersen

## OVERVIEW

### Introduction

Tofersen is an antisense oligonucleoside directed against mutated forms of SOD1 used in the treatment of adults with amyotrophic lateral sclerosis with mutations in the SOD1 gene. Tofersen has been associated with minor liver test abnormalities during therapy but has not been linked instances of clinically apparent liver injury.

### Background

Tofersen (toe fer’ sin) is an antisense oligonucleoside that is directed against the mRNA of the mutated superoxide dismutase 1 (SOD1) gene and is used in the treatment of adults with amyotrophic lateral sclerosis with mutated SOD1. Amyotrophic lateral sclerosis (ALS) is a rare, but invariably fatal neuromuscular disease characterized by progressive loss of motor neurons resulting in muscle weakness, atrophy, and eventual paralysis, leading to death from respiratory failure within 2 to 10 years of onset. Several genes have been associated with an increased risk of ALS including mutated SOD1 which is found in approximately 10% of patients. The mutated SOD1 protein appears to be toxic to motor neurons. Tofersen is an antisense oligonucleoside that is directed to mutated SOD1 and results in degradation of the mRNA and a decrease in mutated SOD1 protein production. In animal models, treatment with tofersen resulted in decreases in SOD1 levels in serum and cerebral spinal fluid (CSF) and slowed the progression of the neuromuscular disease. In the initial preregistration controlled trials, tofersen led to only modest improvements in progressive symptoms and signs of disease but did decrease serum and CSF SOD1 levels and improve surrogate markers of neurodegeneration (serum levels of neurofilament light chain: NfL). In longer term studies, tofersen was found to stabilize symptoms and body weight and to slow disease progression. Tofersen was approved for use in the United States in 2023 for adults with ALS and mutated SOD1 gene. It is available in solution as 100 mg in 15 mL in single use vials under the brand name Qalsody. The usual treatment regimen is 3 loading doses of 100 mg given intrathecally every 14 days, followed by maintenance doses of 100 mg given every 28 days. Side effects are common, mostly attributable to the lumbar puncture required for its administration. Common adverse events include pain, fatigue, arthralgia, myalgia, and an increase in white blood cells in the CSF. Severe adverse events occur in up to 10% of patients including myelitis, radiculitis, papilledema, increased intracranial pressure, and aseptic meningitis.

### Hepatotoxicity

In the initial registration trial of tofersen in ALS, serum aminotransferase elevations above 3 times the upper limit of normal (ULN) occurred in 4% of treated patients, but the elevations were generally transient, mild, and no more frequent than in a placebo-treated patients (3%). With longer term, open label studies, ALT elevations above 3 times ULN arose in 11% of tofersen-treated subjects and were above 5 times ULN in 4%. However, the elevations were not accompanied by symptoms or jaundice, and there were no instances of clinically apparent liver injury or discontinuations because of liver test abnormalities. Since its approval, clinical experience with tofersen has been limited, but there have been no published case reports of clinically apparent liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which tofersen might cause liver injury is not clear. Tofersen is a short (20 mer) oligonucleotide and is metabolized to short sequences or individual nucleotides by tissue and plasma exonucleases. Tofersen is administered intrathecally, but low levels are found in serum. It is not metabolized by P450 enzymes, has no effect on their level of activity, and has not been linked to significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on tofersen therapy are unlikely to be due to the drug therapy and rarely require dose modification or discontinuation. Persistent ALT or AST elevations arising during therapy should lead to evaluation of their possible causes. There is no information on cross sensitivity to liver injury among the various other therapies for ALS.

Drug Class: Neurological Disease Agents, Antisense Oligonucleosides

Drugs for Amyotrophic Lateral Sclerosis: Edaravone, Riluzole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tofersen – Qalsody®

DRUG CLASS

Neurological Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tofersen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tofersen | 2088232-70-4 (https://pubchem.ncbi.nlm.nih.gov/substance/381128259) | C230-H317-N72-O123-P19-S15 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 March 2025

Abbreviations: ALS, amyotrophic lateral sclerosis; CSF, cerebral spinal fluid; SOD1, superoxide dismutase 1.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of antisense therapies such as tofersen).
FDA. Integrated Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/215887Orig1s000IntegratedR.pdf (FDA website with the product labels and integrated review of the data on efficacy and safety provided by the sponsor in support of approval of tofersen as therapy of amyotrophic lateral sclerosis [ALS] with mutations in the SOD1 gene, mentions that mild-to-moderate elevations in serum ALT elevations arose in 4% of tofersen-treated vs 3% of placebo recipients; and while in long term studies up to 11% of participants had ALT elevations, none were associated with jaundice or symptoms or required drug discontinuation).
Miller T, Cudkowicz M, Shaw PJ, Andersen PM, Atassi N, Bucelli RC, Genge A, et al. Phase 1-2 trial of antisense oligonucleotide tofersen for SOD1 ALS. N Engl J Med. 2020;383:109-119. (Among 50 adults with ALS and SOD1 mutations treated with ascending doses of tofersen [20-100 mg] vs placebo for 12 weeks, CSF SOD1 concentrations decreased in a dose-responsive manner and adverse events were largely procedural, pain or post lumbar puncture syndrome; no mention of AL T elevations or hepatotoxicity). 32640130
Miller TM, Cudkowicz ME, Genge A, Shaw PJ, Sobue G, Bucelli RC, Chiò A, et al.; VALOR and OLE Working Group. Trial of antisense oligonucleotide tofersen for SOD1 ALS. N Engl J Med. 2022;387:1099-1110. (Among 108 adults with ALS and SOC1 mutations treated with 8 doses of intrathecal tofersen [100 mg] or placebo over 24 weeks, there were similar changes in functional rating scales in the various groups and procedural adverse events were common, serious neurologic side effects occurring in 7%; no mention of ALT elevations or hepatotoxicity). 36129998
Blair HA. Tofersen: first approval. Drugs. 2023;83:1039-1043. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of tofersen shortly after its approval for use in ALS in the US, discusses the neurological side effects of therapy but does not mention ALT elevations or hepatotoxicity). 37316681
Tofersen (Qalsody) for ALS. Med Lett Drugs Ther. 2023;65:113-114. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of tofersen, discusses neurological side effects but does not mention ALT elevations or hepatotoxicity). 37460141
Wiesenfarth M, Dorst J, Brenner D, Elmas Z, Parlak Ö, Uzelac Z, Kandler K, et al. Effects of tofersen treatment in patients with SOD1-ALS in a "real-world" setting – a 12-month multicenter cohort study from the German early access program. EClinicalMedicine. 2024;69:102495. (Among 24 patients with ALS and SOD1 mutations treated with tofersen for an average of 6 months, progression scales improved slightly and neurofilament heavy chain serum levels declined, while 2 patients had serious adverse events [autoimmune myeloradiculitis and leg weakness], both of whom discontinued therapy as did a third “for no objective medical reason”; no mention of ALT elevations of hepatotoxicity). 38384337
Weiss A, Gilbert JW, Flores IVR, Belgrad J, Ferguson C, Dogan EO, Wightman N, et al. RNAi-mediated silencing of SOD1 profoundly extends survival and functional outcomes in ALS mice. bioRxiv [Preprint]. 2024:2024.06.20.599943. (In transgenic SOD1 mutant ALS mice, knockdown of SOD1 delayed disease onset and preserved neuromuscular integrity, and treatment with a divalent siRNA against SOD1 intraventricularly led to similar SOD1 silencing and extended survival in the mouse model of the disease).
Sabatelli M, Cerri F, Zuccarino R, Patanella AK, Bernardo D, Bisogni G, Tanel R, et al. Long-term treatment of SOD1 ALS with tofersen: a multicentre experience in 17 patients. J Neurol. 2024;271:5177-5186. (Among 17 patients with ALS with SOD1 mutations treated with tofersen for 1 to 2 years, clinical progression scales were stable or improved as compared to periods before starting therapy; no mention of ALT elevations or hepatotoxicity). 38829431
Ludolph A, Wiesenfarth M. Tofersen and other antisense oligonucleotides in ALS. Ther Adv Neurol Disord. 2025;18:17562864251313915. (Review of the use of antisense therapies for ALS such as tofersen and major questions remaining about its use, efficacy and safety, such as use in prevention of ALS by newborn screening for SOD1 mutations, early initiation of therapy, how to measure efficacy, long term safety and autoimmune complications; no mention of hepatotoxicity). 39845577

## OTHER REFERENCE LINKS

1. Recent References on Tofersen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tofersen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tofersen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tofersen)